# Captopril

## OVERVIEW

### Introduction

Captopril is an angiotensin-converting enzyme (ACE) inhibitor used in the therapy of hypertension and heart failure. Captopril is associated with a low rate of transient serum aminotransferase elevations and has been linked to rare instances of acute liver injury.

### Background

Captopril (kap' toe pril) was the first ACE inhibitor to be approved for use in the United States and is still widely used for therapy of hypertension and heart failure. Like other ACE inhibitors, captopril inhibits the conversion of angiotensin I, a relatively inactive molecule, to angiotensin II which is the major mediator of vasoconstriction and volume expansion induced by the renin-angiotensin system. Other enzymes besides that which converts angiotensin I to II may also be inhibited, which may account for some of the side effects of the ACE inhibitors. Captopril was approved for use in the United States in 1981 and current indications are for hypertension, congestive heart failure, left ventricular dysfunction after myocardial infarction, and treatment and prevention of diabetic nephropathy. Captopril is available in 12.5, 25, 50 and 100 mg tablets in many generic forms and formerly under the trade name Capoten. The typical dose of captopril in adults in 25 to 50 mg two or three times daily, and it is administered long term. Captopril is also available in several fixed combinations with hydrochlorothiazide (Capozide and others). Common side effects of captopril and ACE inhibitors in general include dizziness, fatigue, headache, cough, gastrointestinal upset and skin rash.

### Hepatotoxicity

Captopril, like other ACE inhibitors, has been associated with a low rate of serum aminotransferase elevations (<2%) that, in controlled trials, was no higher than with placebo therapy. These elevations were transient and rarely required dose modification. While rare, several dozen cases of clinically apparent liver injury have been reported with captopril therapy. The onset is usually within 2 to 12 weeks of starting therapy and the serum enzyme pattern is typically cholestatic (Case 1). In some instances, cholestasis has been prolonged and relapsing and associated with persistent elevations in serum alkaline phosphatase, suggestive of vanishing bile duct syndrome. Immunoallergic manifestations (rash, fever, eosinophilia) are infrequent and most patients do not develop autoantibodies. Rare instances of captopril injury with a hepatocellular pattern and cases with a long latency (one or more years) have been described as well, a distinctly unusual pattern of drug induced liver injury.

Likelihood score: B (likely but rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the minor serum aminotransferase associated with captopril is not known. The clinically apparent acute liver injury from captopril is likely an idiosyncratic reaction to a metabolite. Captopril is hydrolyzed by the liver to its active metabolite captoprilat and has little further hepatic metabolism.

### Outcome and Management

Most instances of acute liver injury reported with captopril use have been self limited, but there have been rare reports of acute liver failure due to captopril and several reports of cholestatic hepatitis leading to prolonged jaundice. Patients with severe captopril induced acute liver injury and hypersensitivity reactions should avoid use of other ACE inhibitors, although cross sensitivity to liver injury among the members of this class of agents has not always been shown.

References to the safety and potential hepatotoxicity of captopril are given in the Overview section on the Angiotensin-Converting Enzyme (ACE) Inhibitors.

Drug Class: Antihypertensive Agents, Angiotensin-Converting Enzyme Inhibitors

## CASE REPORT

### Case 1. Cholestatic hepatitis due to captopril.

[Modified from: Tabibian N, Alpert L, Alpert E. Captopril-induced liver dysfunction. South Med J 1987; 80: 1173-5. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/3306948)]

A 54 year old man with congestive heart failure and atrial fibrillation on chronic therapy with digoxin, furosemide and isosorbide dinitrate was started on captopril [25 mg three times daily]. One month later he developed mild pruritus, nausea, anorexia and abdominal discomfort but continued taking his prescribed medications. Two months later he noted the onset of jaundice. He had no history of liver disease, alcohol abuse or risk factors for viral hepatitis. He denied fever and rash. Examination showed deep jaundice but no peripheral manifestations of chronic liver disease. Laboratory testing showed total bilirubin of 25 mg/dL with mild elevations in aminotransferases (ALT 73, AST 130 U/L), and marked elevations in alkaline phosphatase (1054 U/L) which had been mildly elevated before captoril therapy (Table). The prothrombin time was normal at 11.8 seconds and eosinophil count at 268/µL. Tests for hepatitis A and B and for autoantibodies were negative. Abdominal ultrasound showed no gallstones or evidence for biliary obstruction, which was confirmed by percutaneous transhepatic cholangiography. A liver biopsy showed intrahepatic cholestasis and changes suggestive of drug induced liver injury. Five days after admission, captopril was stopped while his other medications were continued. Thereafter, he improved rapidly and tests had almost returned to normal when he was last seen a month later.

#### Key Points

Medication: | Captopril (75 mg daily)
Pattern: | Cholestatic (R=0.7)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 4 weeks to symptoms, 12 weeks to jaundice
Recovery: | Partial by 5 weeks
Other medications: | Digoxin, furosemide, isosorbide dinitrate

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | 33 | 338 | 1.3 | Congestive heart failure
12 weeks | 0 | 73 | 1054 | 25.0 | Admission
12.5 weeks | 0 | 61 | 951 | 36.3 | Captopril stopped
13 weeks | 1 day | 60 | 1358 | 31.6
| 5 days | 46 | 683 | 21.8 | Liver biopsy
14 weeks | 9 days | 35 | 536 | 14.3
18 weeks | 5 weeks | 60 | 377 | 3.7
Normal Values | | <40 | <130 | <1.2

#### Comment

The patient developed a cholestatic hepatitis 1 to 3 months after adding captopril to a regimen of therapy for chronic congestive heart failure. Typical of cholestatic drug induced liver injury was the relative paucity of symptoms, despite deep jaundice and the slow rate of recovery which was not complete at the time of the last laboratory test. While the patient had mildly abnormal liver tests before being treated, the clinical presentation and improvement on stopping captopril makes this a convincing case. There have been instances in which patients with captopril induced liver injury have been able to tolerate other ACE inhibitors without complications, but others in which there was evidence of cross reactivity. If patients with ACE inhibitor related cholestatic hepatitis are restarted on another ACE inhibitor, informed consent and careful monitoring for reappearance of liver injury for the first few weeks of therapy is warranted.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Captopril – Generic, Capoten®

DRUG CLASS

Angiotensin-Converting Enzyme Inhibitors

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Captopril)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Captopril | 62571-86-2 | C9-H15-N-O3-S | Captopril Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Captopril: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Captopril/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Captopril: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Captopril)